# Ranitidine

## OVERVIEW

### Introduction

Ranitidine is a histamine type 2 receptor antagonist (H2 blocker) which is widely used for treatment of acid-peptic disease and heartburn. Ranitidine has been linked to rare instances of clinically apparent acute liver injury.

### Background

Ranitidine (ra ni' ti deen) was the second H2 blocker introduced into clinical practice in the United States and remains a commonly used agent for treatment of duodenal and gastric ulcer and gastroesophageal reflux disease. The H2 blockers are specific antagonists of the histamine type 2 receptor, which is found on the basolateral (antiluminal) membrane of gastric parietal cells. The binding of ranitidine to the H2 receptor results in inhibition of acid production and secretion, and improvement in symptoms and signs of acid-peptic disease. The H2 blockers inhibit an early, “upstream” step in gastric acid production and are less potent that the proton pump inhibitors, which inhibit the final common step in acid secretion. Nevertheless, the H2 blockers inhibit 24 hour gastric acid production by about 70% and are most effective in blocking basal and nocturnal acid production. Ranitidine was first approved for use in the United States in 1983 and is now used widely both by prescription and over-the-counter. The listed indications for ranitidine are duodenal and gastric ulcer disease, gastroesophageal reflux and prevention of stress ulcers. Ranitidine is available by prescription in capsules of 150 and 300 mg in several generic forms, and in both oral and parenteral forms under the brand name Zantac. Over-the-counter formulations of ranitidine are usually tablets of 75 mg each. The typical recommended dose of ranitidine for therapy of peptic ulcer disease in adults is 150 mg twice daily or 300 mg once nightly for 4 to 8 weeks, and maintenance doses of 150 mg once daily. Lower, chronic or intermittent doses are used for therapy of heartburn and indigestion. Side effects of ranitidine are uncommon, usually minor, and include diarrhea, constipation, fatigue, drowsiness, headache and muscle aches. Ranitidine is metabolized by, but minimally affects the activity of the hepatic cytochrome P450 enzymes, for which reason it is less likely to lead to drug-drug interactions than is cimetidine.

### Hepatotoxicity

Chronic therapy with ranitidine has been associated with minor elevations in serum aminotransferase levels in 1% to 4% of patients, but similar rates were reported in placebo recipients. The ALT elevations are usually asymptomatic and transient and may resolve without dose modification. Rare instances of clinically apparent liver injury have been reported in patients receiving ranitidine, but the time to onset and pattern of injury has varied greatly (Cases 1-3). Onset can be as short as a few days to as long as several months, but is usually within 6 weeks. The pattern of serum enzyme elevation varies from hepatocellular to cholestatic, most cases being “mixed” hepatocellular-cholestatic. The injury is rarely severe and usually resolves rapidly upon stopping, generally within 4 to 12 weeks. Liver biopsy histology often shows prominent centrolobular necrosis. Immunoallergic features (rash, fever, eosinophilia) can occur (Case 2) but are uncommon, as is autoantibody formation.

Likelihood score: B (very likely but rare cause of clinically apparent liver injury).

### Mechanism of Injury

Ranitidine is metabolized by the microsomal P450 drug metabolizing enzymes and inhibits the function of CYP 3A and 2D6, and injury may be the result of its activation to a toxic intermediate. Rapid recurrence with rechallenge is typical, but features of hypersensitivity are uncommon.

### Outcome and Management

The hepatic injury caused by ranitidine is usually rapidly reversible with stopping the medication (Case 1). Rare instances of acute liver failure have been attributed to it, but ranitidine has not been definitively linked to cases of prolonged cholestasis or vanishing bile duct syndrome. Rechallenge usually causes recurrence and should be avoided. Interestingly, there appears to be little cross reactivity in hepatic injury between ranitidine and cimetidine. If acid suppression is required, use of an unrelated proton pump inhibitor is probably prudent for patients with clinically apparent ranitidine induced liver injury.

The H2 receptor blockers include cimetidine, famotidine, nizatidine, and ranitidine. General references on all four agents are given together after the overview section on H2 Blockers, while specific references are provided after the description of each drug. See also the Proton Pump Inhibitors.

Drug Class: Antiulcer Agents

Other Drugs in the Subclass, Histamine Type 2 Receptor Antagonists: Cimetidine, Famotidine, Nizatidine

## CASE REPORTS

### Case 1. Bland cholestasis attributed to ranitidine therapy.

[Modified from: Ramrakhiani S, Brunt EM, Bacon BR. Possible cholestatic injury from ranitidine with a review of the literature. Am J Gastroenterol 1998; 93: 822-6. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/9625136)]

A 29 year old man developed pruritus after 3 days and jaundice after 14 days of ranitidine therapy (150 mg twice daily) for symptoms of gastroesophageal reflux. He had no history of liver disease, jaundice, alcohol abuse or risk factors for viral hepatitis. He was taking no other medications or over-the-counter products. He complained of dark urine and pruritus, but no mention was made of abdominal pain, nausea or fatigue. Physical examination showed jaundice and excoriations, but no rash, fever or adenopathy. Laboratory testing showed marked elevations in serum bilirubin, but minimal increases in serum aminotransferase and alkaline phosphatase levels (Table). Despite stopping ranitidine, he continued to worsen for the first week after onset with troublesome pruritus and serum bilirubin peaking at 30 mg/dL. A liver biopsy showed canalicular cholestasis with mild inflammation and necrosis. There were increased numbers of eosinophils. Because of the severity of the pruritus, he was treated with ursodiol and a short course of corticosteroids which appeared to result in an improvement in cholestasis. In follow up, off of corticosteroid therapy, serum laboratory tests returned to normal.

#### Key Points

Medication: | Ranitidine (300 mg daily)
Pattern: | Cholestatic (R=0.8)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 2 weeks
Recovery: | 2-3 months
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | Ranitidine (150 mg daily) for 14 days
14 days | 0 | 43 | 105 | 10.8 | Pruritus
16 days | 2 days | 50 | 115 | 12
22 days | 8 days | 70 | 112 | 30
26 days | 12 days | 90 | 155 | 17
32 days | 18 days | 102 | 160 | 14
36 days | 22 days | 105 | 158 | 13
41 days | 27 days | 120 | 135 | 11
50 days | 36 days | 255 | 137 | 6
2 months | 43 days | 280 | 112 | 3
3 months | 3 months | 30 | 50 | 0.5
Normal Values | | <32 | <60 | <1.2

* Some values estimated from Figure 1.

#### Comment

This patient developed bland and somewhat prolonged cholestasis after only two weeks of ranitidine therapy. While the time to onset is somewhat typical of H2-blocker induced liver disease, the cholestatic course with minimal serum enzyme elevations is somewhat atypical and more characteristic of the jaundice associated with use of androgenic steroids, which patients often do not mention or actively deny taking. The prolonged cholestasis was not associated with bile duct damage or ductopenia and recovery was complete by three months after onset.

### Case 2. Imunoallergic cholestatic hepatitis attributed to ranitidine.

[Modified from: Devuyst O, Lefebvre C, Geubel A, Coche E. Acute cholestatic hepatitis with rash and hypereosinophilia associated with ranitidine treatment. Acta Clin Belg 1993; 48: 109-14. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/8392242)]

A 58 year old man with a past history of duodenal ulcer disease underwent a partial colectomy for adenocarcinoma of the rectum and was placed on ranitidine (150 mg daily) during recovery for prevention of recurrent ulcer disease. He had taken ranitidine in the past without side effects or complications. Two weeks later he was readmitted for acute onset of chills and vomiting and was found to have elevations in serum enzymes. He had no history of liver disease or alcohol abuse and had no risk factors for viral hepatitis. He had received isoflurane anesthesia for his colonic surgery and amikacin, ornidazole and lormetazepam in the perioperative period two weeks previously, but was taking no other medications, herbals or over-the-counter preparations. On admission, he was mildly febrile, had a mild erythematous rash over the trunk and was tender over the liver, but did not have jaundice or signs of chronic liver disease. Laboratory testing showed mild elevations in serum alanine aminotransferase (ALT) and alkaline phosphatase (Alk P) levels, which had been normal before surgery (Table). Over the next few days, serum enzyme levels rose and he became jaundiced. The liver test abnormalities were accompanied by a marked eosinophilia. Abdominal ultrasound showed no evidence of biliary obstruction or gallstones. Upper endoscopy was normal. Tests for hepatitis A, B and C were negative as were routine autoantibodies. Ranitidine was stopped on the second hospital day and he began to improve, jaundice clearing in four days and serum enzymes falling to near normal by the time of his discharge 7 days later. When seen in follow up 6 months later, all biochemical laboratory tests were normal.

#### Key Points

Medication: | Ranitidine (150 mg daily)
Pattern: | Cholestatic (R=2.0)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 2 weeks
Recovery: | ~4 weeks
Other medications: | Isoflurane, amikacin, lormetazepam, ornidazole

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Eosinophils (cells/ µL) | Other
Pre | Pre | 25 | 50 | 0.5 | 200
14 days | 0 | 183 | 166 | 1.0 | 350
16 days | 0 | 398 | 371 | 4.4 | 1130
17 days | 1 day | 420 | 420 | | 1800
18 days | 2 days | 305 | 460 | 4.8 | 2000
19 days | 3 days | 230 | 480 | 3.0 | 2300
20 days | 4 days | 160 | 275 | 2.6 | 2100
21 days | 5 days | 135 | 220 | 1.2 | 2200
23 days | 7 days | 60 | 160 | 0.9 | 1500
7 months | 6 months | 25 | 50 | 0.6 | 200
Normal Values* | | <32 | <60 | <1.2

* Some values estimated from Figure 1.

#### Comment

This patient developed a typical cholestatic hepatitis with signs of hypersensitivity (rash, fever and eosinophilia) two weeks after starting ranitidine. While the timing of onset and recovery was compatible with ranitidine induced injury, ornidazole (a metronidazole like antibiotic available in Europe) which was used in the perioperative period is another possible cause of the immunoallergic hepatitis.

### Case 3. Transient aminotransferase elevations during ranitidine therapy.

[Modified from: Barr GD, Piper DW. Possible ranitidine hepatitis. Med J Aust 1981; 2: 421. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/6275248)]

A 63 year old woman with duodenal ulcer disease developed elevations in serum aminotransferase levels during a six week trial of ranitidine therapy. She had no history of liver disease, jaundice, alcohol abuse or risk factors for viral hepatitis. She underwent upper endoscopy which revealed an active duodenal ulcer and was enrolled in a clinical research study of a six week course of ranitidine. She had received cimetidine in the past without complications. Baseline liver tests were normal and there was no change after the first week of treatment. When seen at week two, however, she complained of recent onset of flu-like symptoms and fatigue and her serum aminotransferase levels were elevated (ALT 870 U/L, AST 705 U/L, GGT 470 U/L), but bilirubin and albumin were normal (Table). The total white count was normal with no eosinophilia, but she had a few atypical lymphocytes. She had no rash, fever or lymphadenopathy. Despite the serum enzyme elevations, ranitidine was continued and her symptoms resolved in a few days while serum aminotransferase levels rapidly fell into the normal range. Tests for hepatitis A and B were negative, and serial testing for antibodies to cytomegalovirus, herpes simplex and Epstein Barr virus showed no changes. Antinuclear antibody was negative and smooth muscle antibodies were weakly positive (1:20). While serum ALT and AST became normal, GGT remained elevated for the entire 42 days of therapy, but then fell to normal two weeks later.

#### Key Points

Medication: | Ranitidine (150 mg twice daily)
Pattern: | Hepatocellular (R=unable to calculate)
Severity: | 1+ (serum enzyme elevations with mild symptoms)
Latency: | 2 weeks
Recovery: | 10 days
Other medications: | Diazepam and butylscopolamine during endoscopy

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 35 | 50 | | Endoscopy, ranitidine started
1 week | 0 | 25 | 60
2 weeks | 0 | 870 | 470 | 1.0 | Fatigue
3 weeks | 0 | 325 | 425 | | Symptoms resolved
4 weeks | 0 | 115 | 260
5 weeks | 0 | 60 | 210
6 weeks | 0 | 35 | 275 | | Ranitidine stopped
7 weeks | 8 days | 35 | 190
2 months | 18 days | 35 | 50
Normal Values | | <40 | <65 | <1.2

* Some values estimated from Figure 1.

#### Comment

This patient developed marked serum aminotransferase elevations 2 weeks after starting a 6 week course of ranitidine, which rapidly fell to normal even though ranitidine was continued at the same dosage. While this response might suggest that the injury was unrelated to ranitidine, GGT levels remained elevated during therapy, only falling to normal when ranitidine was stopped.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ranitidine – Generic, Zantac®

DRUG CLASS

Antiulcer Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ranitidine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ranitidine | 66357-35-5 | C13-H22-N4-O3-S | Ranitidine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 January 2018

Zimmerman HJ. H2 Receptors antagonists. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 719-20. (Expert review of hepatotoxicity published in 1999 states that cimetidine and ranitidine, despite enormous use, have been implicated in only a small number of cases of hepatic injury: 39 for cimetidine, 35 for ranitidine and 1 for famotidine, all cases resolving spontaneously and signs of hypersensitivity being rare).
Wallace JL, Sharkey KA. Pharmacotherapy of gastric acidity, peptic ulcers, and gastroesophageal reflux disease. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1309-22. (Textbook of pharmacology and therapeutics) .
Barr GD, Piper DW. Possible ranitidine hepatitis. Med J Aust 1981; 2: 421. (63 year old with duodenal ulcer disease developed malaise 2 weeks after starting ranitidine [bilirubin 1.0 mg/dL, ALT 870 U/L, GGT 470 U/L], which resolved in 10 days despite continuation of ranitidine for 7 weeks, GGT levels becoming normal when it was stopped). 6275248
Takemoto T, Okazaki Y, Okita K, Namiki M, Ishikawa M, Oshiba S, Kurokawa K. Ranitidine: a pilot study in Japan. Scand J Gastroenterol Suppl 1981; 69: 125-8. (Experience in using ranitidine in 42 patients with peptic ulcer disease, 3 patients [7%] developed mild elevations in serum ALT, resolving with continuing ranitidine in one and after stopping in two). 6119776
Brogden RN, Carmine AA, Heel RC, Speight TM, Avery GS. Ranitidine: a review of its pharmacology and therapeutic use in peptic ulcer disease and other allied diseases. Drugs 1982; 24: 267-303. (Extensive review of pharmacology, clinical efficacy and side effects of ranitidine; side effects occur in 3-5% of patients, are largely mild and include rash, headache and dizziness, 1 case of anicteric hepatitis reported; no mention of ALT elevations). 6128216
Cleator IG. Adverse effects of ranitidine therapy. Can Med Assoc J 1983; 129: 405. (62 year old was found to have elevations in Alk P [302 U/L] and AST [249 U/L] 4 weeks after starting ranitidine; a liver biopsy "gave negative results"; switched to cimetidine and enzymes were normal when tested 3 months later). 6309353
Offit K, Sojka DA. Ranitidine. N Engl J Med 1984; 310: 1603. Not in PubMed (Summarized in review articles: 66 year old developed fever 4 weeks after starting ranitidine with ALT 3 times ULN, Alk P 4 times ULN, bilirubin not reported, resolving in 1 week).
Halparin LS. Adverse effects of ranitidine therapy. Can Med Assoc J 1984; 130: 668, 672. (Gives a different clinical history than described by Cleator [1983], that the patient had elevations in Alk P and GGT before starting ranitidine, and that they rose above these levels after 7 months to AST 225 U/L, GGT 1218 U/L and bilirubin 1.5 mg/dL, resolving on stopping ranitidine and alcohol consumption). 6321005
Ireland A, Colin-Jones DG, Gear P, Golding PL, Ramage JK, Williams JG, Leicester RJ, et al. Ranitidine 150 mg twice daily vs 300 mg nightly in treatment of duodenal ulcers. Lancet 1984; 2: 274-6. (Trial of two different doses of ranitidine for duodenal ulcer disease in 102 patients treated for 4 weeks; a 51 year old developed jaundice on day 17 with "mixed picture", but continued therapy until day 28 and rapidly recovered once ranitidine was stopped). 6146821
Proctor JD. Hepatitis associated with ranitidine. JAMA 1984; 251: 1554. (50 year old developed fatigue 15 days after starting ranitidine [bilirubin 1.3 mg/dL, ALT 304 U/L, Alk P 209 U/L], with resolution within 1 week of stopping). 6321809
Jack D, Smith RN; Souza Lima MA; Proctor JD. Hepatitis associated with ranitidine. JAMA 1984; 252: 3253-4. (Letters in response to Proctor [1984], questioning the relatedness of the liver injury to ranitidine therapy and whether the aminotransferase elevations might have resolved even with continuing medication). 6096579
Bredfeldt JE, von Huene C. Ranitidine, acetaminophen, and hepatotoxicity. Ann Intern Med 1984; 101: 719. (42 year old developed dark urine 3 weeks after starting ranitidine [bilirubin 2.1 mg/dL, AST 196 U/L, Alk P 708 U/L], resolution in 1 month of stopping; patient was also taking acetaminophen). 6091515
Souza Lima MA. Hepatitis associated with ranitidine. Ann Intern Med 1984; 101: 207-8. (77 year old developed fatigue 8 days after starting ranitidine [bilirubin 0.3 mg/dL, ALT 132 U/L, Alk P 384 U/L], liver biopsy showing focal necrosis, resolution in 8 days and then tolerated cimetidine without recurrence, but rechallenge with ranitidine for 3 days led to fever, ALT 860 U/L and Alk P 451 U/L). 6331240
Black M, Scott WE Jr, Kanter R. Possible ranitidine hepatotoxicity. Ann Intern Med 1984; 101: 208-10. (3 cases; ages 63, 59 and 19 years on ranitidine for 3-6 weeks, presenting with fever [bilirubin 0.7, 2.1 and 8.8 mg/dL, ALT 157, 81 and 100 U/L, Alk P 152, 360 and 167 U/L], resolving rapidly upon stopping; all 3 patients had previously tolerated cimetidine without liver injury). 6331241
Lauritsen K, Havelund T, Rask-Madsen J. Ranitidine and hepatotoxicity. Lancet 1984; 2: 1471. (81 year old developed jaundice 6 weeks after blood transfusion and starting ranitidine [bilirubin 15.3 mg/dL, ALT 650 U/L, Alk P 724 U/L], resolving in 8 weeks). 6151079
Hegarty JE. Ranitidine and hepatotoxicity. Lancet 1985; 1: 223. (Raises issue of case of ranitidine hepatotoxicity presented by Lauritsen et al. [1984] might have represented hepatitis C as it arose 6 weeks after blood transfusion). 2857299
Desaint B, Alperine M, Legendre C, Florent C, Lévy VG. [Hepatitis caused by ranitidine]. Gastroenterol Clin Biol 1985; 9: 746-7. French. (27 year old developed jaundice 4 days after restarting ranitidine). 4065499
Graham DY, Opekun AR, Smith JL, Schwartz JT. Ranitidine and hepatotoxicity. Ann Intern Med 1985; 102: 416. (50 year old developed rising liver tests over 6 weeks of ranitidine therapy, peaking at bilirubin 2.6 mg/dL, ALT 185 U/L, GGT 1680 U/L, rapid resolution on stopping, but negative rechallenge to 3 day course). 3970492
Karachalios GN. Ranitidine and hepatitis. Ann Intern Med 1985; 103: 634-5. (65 year old developed fatigue, fever and jaundice 3 weeks after starting ranitidine [bilirubin 11.9 mg/dL, AST 920 U/L, Alk P 145 U/L], biopsy showing cholestasis, resolving within 10 days of stopping). 4037565
Hiesse C, Cantarovich M, Santelli C, Francais P, Charpentier B, Fries D, Buffet C. Ranitidine hepatotoxicity in renal transplant patient. Lancet 1985; 1: 1280. (Renal transplant recipient developed increased liver tests 8 days after transplant [ALT 530 U/L, Alk P 84 U/L, bilirubin 3.5 mg/dL], rapid resolution upon stopping and positive rechallenge in 4 days [ALT 52 U/L, bilirubin 1.5 mg/dL]). 2860483
Souza Lima MA. Ranitidine and hepatic injury. Ann Intern Med 1986; 105: 140. (A review of reports to FDA on liver injury found 18 convincing cases due to ranitidine but only 3 for cimetidine; latency of days to 2 months; all recovered). 3717793
Dobbs JH, Muir JG, Smith RN. H2-antagonists and hepatitis. Ann Intern Med 1986; 105: 803. (Letter in response to Souza Lima [1986] arguing that liver injury is rare and occurs in a similar frequency after ranitidine as cimetidine; in comparative registration trials, hepatitis occurred in 1 of 1786 patients on ranitidine vs 1 of 1743 on cimetidine [~0.06%]; in placebo controlled trials, 2 of 2332 ranitidine treated patients developed hepatitis [~0.1%]; all recovered upon withdrawal). 3767169
Black M. Hepatotoxic and hepatoprotective potential of histamine(H2)-receptor antagonists. Am J Med 1987; 83: 68-75. (Review of hepatotoxicity of cimetidine and ranitidine and their potential role in ameliorating acetaminophen hepatotoxicity, perhaps via their inhibition of P450 activity). 2892410
Dobrilla G, De Pretis G, Piazzi L, Boero A, Camarri E, Crespi M, Fontana G, et al. Comparison of once-daily bedtime administration of famotidine and ranitidine in the short-term treatment of duodenal ulcer. A multicenter, double-blind, controlled study. Scand J Gastroenterol Suppl 1987; 134: 21-8. (Controlled trial comparing famotidine and ranitidine in 234 patients with duodenal ulcer disease; all had normal ALT levels at the end of therapy except for one [chronic alcoholic] patient who developed elevated aminotransferase levels on famotidine; no details given). 2889255
Lewis JH. Hepatic effects of drugs used in the treatment of peptic ulcer disease. Am J Gastroenterol 1987; 82: 987-1003. (Thorough review of hepatotoxicity of antiulcer medications; 10 published cases of hepatotoxicity due to cimetidine and 12 for ranitidine, none fatal and not all convincingly due to the medication; little information available on famotidine or nizatidine). 2889354
Cherqui B, Desaint B, Legendre C, Lévy VG. [Fatal hepatitis in a female patient treated with ranitidine]. Gastroenterol Clin Biol 1989; 13: 952-3. French. (60 year old developed jaundice and confusion 12 weeks after starting ranitidine [bilirubin 13.5 mg/dL, ALT 60 times ULN, Alk P 5.5 times ULN, prothrombin index 17%], with progressive hepatic failure and death 6 days later; ANA and SMA positive, previous use of cimetidine; autopsy showed massive necrosis and no fibrosis). 2612841
Vial T, Goubier C, Bergeret A, Cabrera F, Evreux JC, Descotes J. Side effects of ranitidine. Drug Saf 1991; 6: 94-117. (Extensive review of safety of ranitidine; among 4532 patients treated with ranitidine in clinical trials, 4 cases of hepatitis were reported, but their relationship to ranitidine was doubtful; 12 case reports have been published with onset in days to 6 weeks and variable clinical presentations). 2043287
van Bommel EF, Meyboom RH. [Liver damage caused by ranitidine]. Ned Tijdschr Geneeskd 1992; 136: 435-7. Dutch. (Six cases of liver injury attributed to ranitidine reported to Netherlands Center for Monitoring Adverse Reactions to Drugs, ages 43-69 years, arising after 1-12 weeks, with bilirubin 1.2-11.9 mg/dL, ALT 267-1150 U/L, Alk P 104-600 U/L, 2 with eosinophilia and rash, all recovered). 1542370
Polunina TE, Fomichev VI, Vasil'ev AP. [Acute drug-induced hepatitis in a patient with peptic ulcer]. Klin Med (Mosk) 1992; 70: 102-3. Russian. 1507799
Devuyst O, Lefebvre C, Geubel A, Coche E. Acute cholestatic hepatitis with rash and hypereosinophilia associated with ranitidine treatment. Acta Clin Belg 1993; 48: 109-14. (58 year old developed nausea, rash and fever 2 weeks after surgery and starting ranitidine [bilirubin 1.0 rising to 4.8 mg/dL, ALT 183 to 398 U/L, Alk P 166 to 480 U/L and eosinophilia], with rapid resolution; patient also received ornidazole: Case 2). 8392242
Lázaro M, Compaired JA, De La Hoz B, Igea JM, Marcos C, Dávila I, Losada E. Anaphylactic reaction to ranitidine. Allergy 1993; 48: 385-7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%208368468) (22 year old developed urticaria and laryngeal spasm 20 minutes after restarting ranitidine responding to epinephrine, positive skin test to ranitidine, but not other H2 blockers and positive rechallenge test to oral ranitidine).
Ament PW, Roth JD, Fox CJ. Famotidine-induced mixed hepatocellular jaundice. Ann Pharmacother 1994; 28: 40-2. (55 year old developed jaundice following treatment with 1 week of ranitidine and 1 week of famotidine [bilirubin 7.1 mg/dL, ALT 305 U/L, Alk P 182 U/L], with rapid resolution on stopping). 8123957
García Rodríguez LA, Ruigómez A, Jick H. A review of epidemiologic research on drug-induced acute liver injury using the general practice research data base in the United Kingdom. Pharmacotherapy 1997; 17: 721-8. (Combined analysis of 8 epidemiologic studies using the UK General Practice Research Database estimated incidence rates of acute liver injury to be highest for isoniazid and chlorpromazine [4 and 1.3 per 1000 users], intermediate for amoxicillin-clavulanate, cimetidine and ranitidine [2.3, 2.3 and 0.9 per 10,000], and lowest for trimethoprim/sulfamethoxazole, omeprazole, amoxicillin and nonsteroidals [5.2, 4.3, 3.9 and 3.7 per 100,000]). 9250549
García Rodríguez LA, Wallander MA, Stricker BH. The risk of acute liver injury associated with cimetidine and other acid-suppressing anti-ulcer drugs. Br J Clin Pharmacol 1997; 43: 183-8. (Case control study in cohort of 100,000 users of antiulcer drugs in a UK general practice database; 33 cases of acute liver injury found, 12 on cimetidine for a relative risk [RR] of 5.5, 1 on omeprazole and 5 on ranitidine did not raise RR above baseline. Latency was <2 month in 80% of cases; most antiulcer drug cases had hepatocellular or mixed enzyme patterns [15 of 18]). 9131951
Ramrakhiani S, Brunt EM, Bacon BR. Possible cholestatic injury from ranitidine with a review of the literature. Am J Gastroenterol 1998; 93: 822-6. (29 year old developed pruritus after 3 days and jaundice after 2 weeks of ranitidine therapy [bilirubin 10.8 rising to 30 mg/dL, ALT 51, Alk P 105 U/L], with resolution in 3 months of stopping; biopsy showed intrahepatic cholestasis; clinical presentation similar to androgenic steroid hepatotoxicity: Case 1). 9625136
Luparini RL, Rotundo A, Mattace R, Marigliano V. [Possibly ranitidine-induced autoimmune hepatitis]. Ann Ital Med Int 2000; 15: 214-7. Italian. (46 year old with multiple sclerosis developed weakness 8 days after starting prednisone and ranitidine [bilirubin 3 mg/dL, ALT 2739 U/L, Alk P 90 U/L], with prompt recovery on stopping and recurrence on restarting ranitidine [bilirubin 1.5 mg/dL, ALT 1088 U/L]). 11059062
Ribeiro JM, Lucas M, Baptista A, Victorino RM. Fatal hepatitis associated with ranitidine. Am J Gastroenterol 2000; 95: 559-60. (66 year old developed jaundice 2 weeks after starting ranitidine [bilirubin 11.4 mg/dL, ALT 1000 U/L, Alk P 150 U/L, protime 13 seconds], progressing to hepatic failure and death 1 month later; also on cetirizine, propranolol and mexazolam). 10685778
Fisher AA, Le Couteur DG. Nephrotoxicity and hepatotoxicity of histamine H2 receptor antagonists. Drug Saf 2001; 24: 39-57. (Review of renal and hepatic complications of H2 blocker therapy). 11219486
Liberopoulos EN, Nonni AB, Tsianos EV, Elisaf MS. Possible ranitidine-induced cholestatic jaundice. Ann Pharmacother 2002; 36: 172. (73 year old given nimesulide for pain for 2 days and then ranitidine for abdominal upset, developing pruritus after 4 days and jaundice after 3 weeks of ranitidine [bilirubin 15.6 mg/dL, ALT 78 U/L, Alk P 299 U/L], worsening over 1 week and then resolving in 50 days). 11816250
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to an H2 blocker or proton pump inhibitor). 15390328
de Abajo FJ, Montero D, Madurga M, García Rodríguez LA. Acute and clinically relevant drug-induced liver injury: a population based case-control study. Br J Clin Pharmacol 2004; 58: 71-80. (Analysis of General Practice Research Database from UK on 1.6 million persons from 1994-2000 found 128 cases of drug induced liver injury [2.4/100,000 person years]; 3 cases were attributed to cimetidine for an odds ratio of 2.0 compared to controls [n=5000], which was not statistically significant). 15206996
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Survey of all cases of DILI with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002; 103 cases identified as highly probable, probable or possible, one case attributed to ranitidine and one to omeprazole). 16165719
Kantarçeken B, Cetinkaya A, Bülbüloglu E, Yerhan H, Uçar MA. Severe liver enzyme elevation due to single-dose ranitidine in a pregnant woman. Turk J Gastroenterol 2006; 17: 242-3. (36 year old pregnant woman developed serum enzyme elevations two days after starting ranitidine for gastritis [bilirubin 3.7 mg/dL, ALT 1153 U/L, Alk P 88 U/L, protime 11.9 sec], resolving 7 days after stopping). 16941266
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25: 1401-9. (Population based survey of 126 cases of acute liver injury due to drugs between 1993-1999 in Spain; 8 were attributed to ranitidine alone [incidence 5.1/100,000 person-years] and 5 to omeprazole alone [2.1/100,000]). 17539979
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 2 were attributed to ranitidine, none to cimetidine or omeprazole). 18955056
Foti C, Cassano N, Panebianco R, Calogiuri GF, Vena GA. Hypersensitivity reaction to ranitidine: description of a case and review of the literature. Immunopharm Immunotox 2009; 31: 414-6. (47 year old developed anaphylaxis after intravenous ranitidine despite having taken ranitidine orally without difficulty and absence of other allergies and negative skin test). 19694603
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, there were no antiulcer agents in the top 40 causes). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were due to ranitidine or other antiulcer medications). 20949552
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most commonly implicated agents being nimesulide [n=53], cyproterone [n=18], nitrofurantoin [n=17] and antituberculosis drugs [n=13]; no case was linked to ranitidine or other antiulcer agent or H2 blocker). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 6 cases were attributed to antiulcer medications, 3 to ranitidine and 3 to proton pump inhibitors). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Ranitidine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ranitidine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ranitidine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ranitidine)